# Rasburicase

## OVERVIEW

### Introduction

Rasburicase is a parenterally administered, recombinant urate oxidase that is used in combination with xanthine oxidase inhibitors in the therapy of severe hyperuricemia due to tumor lysis syndrome after initiation of cancer chemotherapy in treatment of malignant diseases. Rasburicase has been associated with serum enzyme elevations during therapy and to rare instances of hypersensitivity reactions that can be accompanied by liver injury.

### Background

Rasburicase (ras bure’ i kase) is a DNA recombinant urate oxidase derived from the fungus Aspergillus flavus. Urate oxidase is an enzyme that catalyzes the metabolism of uric acid to allantoin, which is an inert and inactive molecule that, unlike uric acid, is rapidly excreted in the urine. Infusions of rasburicase lower serum uric acid levels by hastening its excretion and have been shown to be effective in rapidly lowering uric acid levels in patients with tumor lysis syndrome after initiation of cancer chemotherapy. Rasburicase was approved for use in the treatment and prevention of hyperuricemia due to tumor lysis syndrome after cancer chemotherapy in the United States in 2002. Rasburicase is available as a powder for reconstitution in vials of 1.5 and 7.5 mg under the brand name Elitek. The recommended dose is 0.2 mg/kg given intravenously once daily for up to 5 days. Common side effects of rasburicase include nausea, vomiting, fever, peripheral edema, anxiety, headache, abdominal pain, constipation and diarrhea. Severe adverse reactions can include local infusion reactions, hypersensitivity reactions, anaphylaxis and hemolytic anemia with methemoglobinemia in patients with G6PD deficiency.

### Hepatotoxicity

In prelicensure clinical trials, serum enzyme elevations were not uncommon (4% to 24%) and were occasionally above 5 times ULN (<1%) during rasburicase therapy. These elevations generally resolved rapidly once rasburicase was discontinued. Because patients receiving rasburicase were typically receiving cancer chemotherapy and other drugs for hyperuricemia such as allopurinol, the liver enzyme elevations observed could not always be attributed to rasburicase. Subsequent to its approval and more wide scale use, rasburicase has been linked to hypersensivity reactions that may be accompanied by marked serum ALT and AST elevations with mild jaundice. In at least one instance, these abnormalities recurred upon re-exposure to rasburicase. These reactions generally arise within hours of administration of rasburicase and resolve rapidly with its discontinuation with or without the use of corticosteroids. Rasburicase has not been linked to instances of acute liver failure or chronic liver injury. Thus, rasburicase is a well-known cause of hypersensivity reactions, some of which may be accompanied by hepatic injury.

Likelihood score: D (possible cause of clinically apparent liver injury accompanying hypersensitivity reactions).

### Mechanism of Injury

Rasburicase is a recombinant protein and is metabolized to amino acids by serum and tissue proteases, and is unlikely to have any direct hepatotoxic potential. The marked liver test abnormalities noted in some patients treated with rasburicase were associated with other features of hypersensitivity.

### Outcome and Management

The serum enzyme elevations during rasburicase therapy are usually mild-to-moderate in severity and rarely require dose modification. Hypersensitivity reactions to rasburicase can be accompanied by mild-to-moderate liver injury. Therapy should be directed at the signs and symptoms of hypersensitivity rather than liver injury itself.

Drug Class: Antigout Agents

## CASE REPORT

### Case 1. Hypersensitivity reaction with hepatic involvement caused by rasburicase.

[Modified from: Viel S, Pescarmona R, Belot A, Nosbaum A, Lombard C, Walzer T, Bérard F. A case of type 2 hypersensitivity to rasburicase diagnosed with a natural killer cell activation assay. Front Immunol 2018; 9: 110. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/29434608)]

A 62 year old man with leukemia developed fever and liver test abnormalities during his fourth course of chemotherapy with pentostatin and tumor lysis syndrome prophylaxis using allopurinol and rasburicase. His white blood cell counts were elevated and he was admitted for therapy of suspected sepsis. His medications were stopped. He had no previous history of liver disease, alcohol abuse or risk factors for viral hepatitis. Laboratory testing showed marked elevations in serum aminotransferase levels (ALT 1102 U/L, AST 773 U/L and LDH 1339 U/L with mild hyperbilirubinemia (3.3 mg/dL) and decrease in the prothrombin index (46%) (Table). His condition improved rapidly and he was discharged. Two months later he was evaluated for hypersensitivity to rasburicase with skin tests. An hour after the single dose of rasburicase (5.5 mg), he developed fever (39.5 ^o^C) and liver tests were again raised.

#### Key Points

Medication: | Rasburicase
Pattern: | Hepatocellular
Severity: | 3+ (jaundice, hospitalization)
Latency: | 4 months
Recovery: | Within 2 months
Other medications: | Allopurinol, pentostatin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | GGT (U/L) | Bilirubin (mg/dL) | Other
4 months | 0 | 1102 | 307 | 3.3 | Fever and leukocytosis
| 2 days | 863 | 225 | 5.9 | Prothrombin ratio [PR] 46%
| Discharged, chemotherapy withheld
6 months | 2 months | 43 | 22 | 0.4 | PR 98%
| Skin tested with rasburicase
| 3 hours | 73 | 99 | 1.0 | PR 90%
| 6 hours | 257 | 202 | 1.5 | PR 77%
| 24 hours | 220 | 171 | | PR 54%
Normal Values | | <55 | <64 | <1.2

#### Comment

This patient presented with a hypersensitivity reaction with hepatic involvement resulting in mild jaundice, but a self-limited course. He was later evaluated with skin testing for drug allergy in an attempt to show whether the reaction was due to rasburicase versus allopurinol or pentostatin. After a single intradermal injection of rasburicase, he developed fever followed by elevations in serum aminotransferase levels and total bilirubin. Thus, the role of rasburicase in the reaction was fairly convincingly documented.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rasburicase – Elitek®

DRUG CLASS

Antigout Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Rasburicase)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Rasburicase | 134774-45-1 | Protein | Complex Polypeptide

## ANNOTATED BIBLIOGRAPHY

References updated: 21 May 2018

Zimmerman HJ. Drugs used to treat gout. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 543-4. (Textbook of hepatotoxicity published in 1999 and before the availability of rasburicase).
Grosser T, Smyth E, FitzGerald GA. Pharmacotherapy of gout. Anti-inflammatory, antipyretic and analgesic agents; pharmacotherapy of gout. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 994-1000. (Textbook of pharmacology and therapeutics).
Pui CH, Jeha S, Irwin D, Camitta B. Recombinant urate oxidase (rasburicase) in the prevention and treatment of malignancy-associated hyperuricemia in pediatric and adult patients: results of a compassionate-use trial. Leukemia 2001; 15: 1505-9. (Among 173 children and 72 adults receiving cancer chemotherapy who were treated with rasburicase, all had a rapid decline in serum uric acid, usually into the normal range and side effects included vomiting, itching, urticarial, rash, fever, headache and myalgia). 11587206
Rasburicase (Elitek) for hyperuricemia. Med Lett Drugs Ther 2002; 44 (1143): 96-7. (Concise review of the indications, pharmacology, clinical efficacy, side effects and costs of rasburicase shortly after its approval for use in the US mentions anaphylactic reactions, but not ALT elevations or liver injury). 12432325
Coiffier B, Mounier N, Bologna S, Fermé C, Tilly H, Sonet A, Christian B, et al.; Groupe d'Etude des Lymphomes de l'Adulte Trial on Rasburicase Activity in Adult Lymphoma. Efficacy and safety of rasburicase (recombinant urate oxidase) for the prevention and treatment of hyperuricemia during induction chemotherapy of aggressive non-Hodgkin's lymphoma: results of the GRAAL1 study. J Clin Oncol 2003; 21: 4402-6. (Among 100 patients with lymphoma undergoing chemotherapy who received rasburicase infusions, uric acid levels were controlled in all patients and none required dialysis during chemotherapy; therapy was stopped early in 3 patients for ALT elevations above 5 times ULN, which rapidly resolved). 14581437
Jeha S, Kantarjian H, Irwin D, Shen V, Shenoy S, Blaney S, Camitta B, et al. Efficacy and safety of rasburicase, a recombinant urate oxidase (Elitek), in the management of malignancy-associated hyperuricemia in pediatric and adult patients: final results of a multicenter compassionate use trial. Leukemia 2005; 19: 34-8. (Among 658 children and 338 adults with malignancies who received rasburicase at the time of chemotherapy, uric acid levels fell and the only nonresponders had discontinued therapy early; side effects were rare but included hemolytic anemia due to G6PD deficiency, renal insufficiency, hypersensitivity reactions, but only one patient had ALT elevations above 5 times ULN). 15510203
Kikuchi A, Kigasawa H, Tsurusawa M, Kawa K, Kikuta A, Tsuchida M, Nagatoshi Y, et al. A study of rasburicase for the management of hyperuricemia in pediatric patients with newly diagnosed hematologic malignancies at high risk for tumor lysis syndrome. Int J Hematol 2009; 90: 492-500. (Among 30 children with hematologic malignancies given rasburicase for 5 days during initial chemotherapy, serum uric acid levels remained below 6.5 mg/dL in all except one patient; ALT elevations above 5 times ULN occurred in 70% of children, but were attributed to the chemotherapy rather than rasburicase). 19701676
Ishizawa K, Ogura M, Hamaguchi M, Hotta T, Ohnishi K, Sasaki T, Sakamaki H, et al. Safety and efficacy of rasburicase (SR29142) in a Japanese phase II study. Cancer Sci. 2009; 100 (2): 357-62. (Among 50 patients with lymphoma or leukemia treated with rasburicase for 5 days starting after the first dose of chemotherapy, serum uric acid levels fell and were less than 7.5 mg/dL in all, while side effects included ALT elevations in 24% [above 5 times ULN in 4%], which resolved after therapy in all and hypersensitivity reactions in 3 patients [6%]). 19076979
Cortes J, Moore JO, Maziarz RT, Wetzler M, Craig M, Matous J, Luger S, et al. Control of plasma uric acid in adults at risk for tumor Lysis syndrome: efficacy and safety of rasburicase alone and rasburicase followed by allopurinol compared with allopurinol alone--results of a multicenter phase III study. J Clin Oncol 2010; 28: 4207-13. (Among 273 children with hematologic malignancies treated with rasburicase, allopurinol or both for 5 days at the start of chemotherapy, uric acid responses were more frequent and rapid with rasburicase, and hypersensitivity reactions arose in 4% and liver test abnormalities in 1% of rasburicase recipients). 20713865
Galardy PJ, Hochberg J, Perkins SL, Harrison L, Goldman S, Cairo MS. Rasburicase in the prevention of laboratory/clinical tumour lysis syndrome in children with advanced mature B-NHL: a Children's Oncology Group Report. Br J Haematol 2013; 163: 365-72. (Among 76 children undergoing cytoreductive therapy in preparation of hematopoietic cell transplantation who received rasburicase to prevent tumor lysis syndrome, 3 patients developed hypersensitivity symptoms, but there were no serious adverse events attributed to the rasburicase therapy). 24032600
Digumarti R, Sinha S, Nirni SS, Patil SG, Pedapenki RM. Efficacy of rasburicase (recombinant urate oxidase) in the prevention and treatment of malignancy-associated hyperuricemia: an Indian experience. Indian J Cancer 2014; 51: 180-3. (Among 88 patients at high risk of tumor lysis syndrome from chemotherapy who received rasburicase, uric acid levels decreased by an average of 75% and there were “no significant changes in … biochemical parameters from baseline” and no serious adverse events thought to be related to rasburicase). 25104205
Drugs for gout. Med Lett Drugs Ther 2014; 56 (1438): 22-4. (Update on medications for gout discusses the urate lowering agents allopurinol, febuxostat, probenecid and pegloticase, but not lesinurad or rasburicase). 24791281
Baldo BA. Enzymes approved for human therapy: indications, mechanisms and adverse effects. BioDrugs 2015; 29: 31-55. (Review of enzymes that are approved for use in the US including those used for enzyme replacement therapy [for Gaucher, Fabry, Pompe, and several MPS] as well as those for specific diseases [dornase for cystic fibrosis, alteplase for myocardial infarction and stoke, L-asparaginase for cancer and pegloticase and rasburicase for hyperuricemia and gout]; no mention of ALT elevations or hepatotoxicity except for L-asparaginase). 25648140
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury in the US collected between 2004 and 2012, 8 cases were attributed to drugs used for gout [allopurinol in 7 and febuxostat in 1], but no cases were attributed to pegloticase or rasburicase). 25754159
Tamura K, Kawai Y, Kiguchi T, Okamoto M, Kaneko M, Maemondo M, Gemba K, et al. Efficacy and safety of febuxostat for prevention of tumor lysis syndrome in patients with malignant tumors receiving chemotherapy: a phase III, randomized, multi-center trial comparing febuxostat and allopurinol. Int J Clin Oncol 2016; 21 (5): 996-1003. (Among 100 patients with malignancies undergoing chemotherapy who were treated prophylactically with either allopurinol or febuxostat, the rate and degree of uric acid decline and side effects were similar in the two groups, and 1 patient in each group had serum ALT elevations [both were less than 3 times ULN]). 27017611
Viel S, Pescarmona R, Belot A, Nosbaum A, Lombard C, Walzer T, Bérard F. A case of type 2 hypersensitivity to rasburicase diagnosed with a natural killer cell activation assay. Front Immunol 2018; 9: 110. (62 year old man developed fever and jaundice during a 4th course of chemotherapy while receiving allopurinol and rasburicase [bilirubin 3.3 mg/dL, ALT 1162 U/L, GGT 307 U/L, leukocytosis], which rapidly resolved on stopping but recurred several months later after a skin test challenge with rasburicase [bilirubin 1.5 mg/dL, ALT 257 U/L, GGT 202 U/L], resolving rapidly). 29434608

## OTHER REFERENCE LINKS

1. Recent References on Rasburicase: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Rasburicase/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Rasburicase: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rasburicase)